# Odevixibat

## OVERVIEW

### Introduction

Odevixibat is an orally available inhibitor of the ilieal bile salt transporter which is used to treat severe pruritus in patients with cholestatic liver disease such as progressive familial intrahepatic cholestasis (PFIC) and Alagille syndrome. Odevixibat is associated with transient serum enzyme elevations particularly with long term therapy which may be accompanied by worsening of the underlying liver disease, but it has not been linked to instances of acute, clinically apparent liver injury with jaundice, although experience with its use has been limited.

### Background

Odevixibat (oh” de vix' i bat) is a small molecule inhibitor of the ileal bile acid transporter and is used to treat the pruritus of severe cholestatic liver diseases including two causes of neonatal jaundice: progressive familial intrahepatic cholestasis (PFIC) and Alagille syndrome. Inhibition of the bile acid transporter blocks the reabsorption of bile salts in the terminal ileum and thereby lowers levels of serum bile acids that are raised in patients with chronic cholestatic diseases such as PFIC. Three major forms of PFIC are known, due to genetic abnormalities in various hepatic biliary transporters: PFIC-1 due to the ATP8B1 protein (gene name FIC1), PFIC-2 to the bile acid exporter protein (BSEP: gene name ABCB11), and PFIC-3 to multi-drug resistant-3 protein (MDR3: gene name ABCB4). Children with PFIC develop progressive cholestatic liver injury with marked increases in serum total bile acids, variable degrees of symptoms of pruritus (itching) and fatigue which can be disabling. Most children have progressive cholestatic liver injury and eventually require liver transplantation. Odevixibat was approved for use in the United States in 2021 as therapy of severe pruritus in children with PFIC. In 2023, indications were extended to children pruritus due to Alagille syndrome, a severe inherited disease which, like PFIC is marked by cholestatic liver injury and severe itching. It is under evaluation as therapy for other severe forms of cholestatic liver injury but is not formally approved for those uses. Odevixibat is available under the brand name Bylvay in capsules of 400 and 1200 µg to be swallowed and as pellets contained in 200 and 600 µg capsules to be opened and sprinkled on soft food or dissolved in liquid for administration to children who cannot swallow capsules. In children with PFIC, the recommended initial dose is 40 µg/kg once daily which after several months can be increased up to 120 µg/kg daily based upon efficacy and tolerance. In children with Alagille syndrome, the recommended dose is 120 µg/kg daily without an initial lower dose. Odevixibat therapy can be associated with symptoms of diarrhea, abdominal pain, nausea and vomiting, and serum aminotransferase elevations, but these adverse events can also occur in untreated children with PFIC and Alagille syndrome. Odevixibat acts locally on the bile acid transporter in the distal ileum and has little systemic absorption. Severe adverse events are rare, but long term therapy can be associated with fat-soluble vitamin deficiencies for which reason prospective monitoring of serum levels of these vitamins is recommended.

### Hepatotoxicity

In trials of odevixibat in children with cholestatic liver diseases, serum ALT elevations of greater than 3 times ULN arose in 8% to 11% of treated participants and were particularly common with long term therapy. However, children with PFIC typically have serum ALT and AST elevations, and it was difficult to establish whether mild-to-moderate serum enzyme elevations were due to odevixibat therapy or to the spontaneous fluctuations that occur with the underlying disease. Nevertheless, the product label for odevixibat mentions that 6 patients in pre-registration clinical trials developed drug-induced liver injury, two of whom required liver transplantation. Since approval of odevixibat, there have been no published cases of clinically apparent acute liver injury with jaundice or hepatic decompensation in children treated with odevixibat, although the total clinical experience with its use is limited.

Likelihood score: C (probable uncommon cause of worsening of liver injury in patients with chronic cholestatic liver disease).

### Mechanism of Injury

The mechanism by which odevixibat might cause liver injury is not known. It has little oral absorption and systemic levels are minimal. The serum aminotransferase elevations that occur with therapy may be due to its effects on absorption of fat soluble vitamins or medications, or to fluxes in the bile acid pool, or to changes in the intestinal microbiome due to changes in bile acid concentrations.

### Outcome and Management

While chronic therapy with odevixibat can be associated with mild-to-moderate serum aminotransferase elevations, it has not been linked to cases of acute, clinically apparent liver injury. Because of the frequency of enzyme elevations detected during therapy, the product label for odevixibat recommends obtaining baseline liver tests before initiation of treatment and monitoring levels during therapy. Any ALT or AST elevation associated with symptoms or jaundice should lead to discontinuation. Moderate elevations above baseline without symptoms, however, can be managed with dose modification or interruption. There is no known cross sensitivity of the hepatic injury from odevixibat with other agents used to treat pruritus. Because of the similarity in chemical structure and mechanism of action, there may be cross sensitivity to side effects with maralixibat, another FDA approved ileal bile acid transporter inhibitor used to treat the pruritus of PFIC and Alagille syndrome.

Drug Class: Ileal Bile Acid Transporter (IBAT) Inhibitors

Other Drugs in the Subclass, Pruritus Agents: Maralixibat, Linerixibat

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Odevixibat – Bylvay®

DRUG CLASS

Ileal Bile Acid Transporter (IBAT) Inhibitors

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Odevixibat)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Odevixibat | 501692-44-0 | C37-H48-N4-O8-S2

## ANNOTATED BIBLIOGRAPHY

References updated: 01-April-2026

Abbreviations: PFIC, progressive familial intrahepatic cholestasis; ULN, upper limit of normal.

Zimmerman HJ. Oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 697-8. (Expert review of hepatotoxicity published in 1999 before the availability of inhibitors of the ileal bile acid transporter).
Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013. (Multi-authored textbook of hepatotoxicity published in 2013, does not discuss inhibitors of the ileal bile acid transporter).
Fuchs CD, Halilbasic E, Trauner M. Pathophysiologic basis of alternative therapies for cholestasis. In, Arias IM, Alter HJ, Boyer JL, Cohen DE, Shafritz DA, Thorgeirsson SS, Wolkoff AW. The Liver: biology and pathobiology. 6th ed. Hoboken, NJ: Wiley Blackwell, 2020, pp 364-77. (Textbook of liver physiology and disease).
FDA Medical Review of NDA for Odevixibat: Pages 79-86.
https://www.accessdata.fda.gov/drugsatfda_docs/nda/2021/215498Orig1s000IntegratedR.pdf (FDA website with product labels and integrated review of the efficacy and safety of odevixibat mentions that serum aminotransferase and bilirubin elevations were frequent in patients with PFIC at baseline, but that further increases were more frequent in odevixibat- than placebo-recipients, ALT in 9.5% vs 0% and bilirubin in 19% vs 5%, as well as treatment interruptions due to liver test abnormalities (16% vs 10%).
Tiessen RG, Kennedy CA, Keller BT, Levin N, Acevedo L, Gedulin B, van Vliet AA, et al. Safety, tolerability and pharmacodynamics of apical sodium-dependent bile acid transporter inhibition with volixibat in healthy adults and patients with type 2 diabetes mellitus: a randomised placebo-controlled trial. BMC Gastroenterol. 2018;18:3. (Among 11 patients with type 2 diabetes and 50 healthy volunteers treated with volixibat [n= 46 in dose of 0.5 to 10 mg] or placebo [n=15] daily for 28 days, there were no significant changes in serum glucose or lipid levels between the two groups and while there were “individual” changes from baseline in some laboratory tests, “no clinically relevant changes were seen” ). 29304731
Palmer M, Jennings L, Silberg DG, Bliss C, Martin P. A randomised, double-blind, placebo-controlled phase 1 study of the safety, tolerability and pharmacodynamics of volixibat in overweight and obese but otherwise healthy adults: implications for treatment of non-alcoholic steatohepatitis. BMC Pharmacol Toxicol. 2018;19:10. (Among 84 overweight or obese healthy volunteers treated with volixibat [20 to 80 mg daily] or placebo for 12 days, volixibat therapy was associated with a 4-fold increase in bile acid excretion, a 6-fold increase in serum C4, despite no or barely detectable volixibat in plasma, while side effects occurred in all drug recipients, usually mild to moderate diarrhea starting on day one, but 4 treated patients [and no controls] developed ALT levels above twice ULN, without symptoms or jaundice, and all resolving spontaneously). 29548345
Kamath BM, Spino C, McLain R, Magee JC, Fredericks EM, Setchell KD, Miethke A, et al.; Childhood Liver Disease Research Network (ChiLDReN). Unraveling the relationship between itching, scratch scales, and biomarkers in children with Alagille syndrome. Hepatol Commun. 2020;4:1012-1018. (Among 37 children with Alagille syndrome, instruments to measure pruritus [the symptom of itching vs the physical findings of scratching] correlated poorly with bile salt, bilirubin and GGT levels, but symptom of itching did correlate with some elements of quality of life including fatigue and sleep disturbance). 32626833
Karpen SJ, Kelly D, Mack C, Stein P. Ileal bile acid transporter inhibition as an anticholestatic therapeutic target in biliary atresia and other cholestatic disorders. Hepatol Int. 2020;14:677-689. (Review of the mechanism of action and rationale for use of ileal bile acid transporter inhibitors as therapy of cholestatic liver diseases in children, such as biliary atresia and Alagille syndrome). 32653991
Slavetinsky C, Sturm E. Odevixibat and partial external biliary diversion showed equal improvement of cholestasis in a patient with progressive familial intrahepatic cholestasis. BMJ Case Rep. 2020;13:e234185. (15 month old boy with severe pruritus due to PFIC-2 [bile salt exporter protein deficiency) had marked decline in serum bile acids [124 to 6.5 µmol/L] and improvements in symptoms during a 4 week course of odevixibat, but return of laboratory abnormalities and symptoms with stopping, and then similar degree of improvements in bile acids [276 to <1 µmol/L] and symptoms after partial external biliary diversion). 32601135
Baumann U, Sturm E, Lacaille F, Gonzalès E, Arnell H, Fischler B, Jørgensen MH, et al. Effects of odevixibat on pruritus and bile acids in children with cholestatic liver disease: Phase 2 study. Clin Res Hepatol Gastroenterol. 2021;45:101751. (Among 20 children [ages 1 to 17 years] with PFIC [n=13], Alagille syndrome [n=6], biliary atresia [n=3] or other severe cholestatic liver disease [n=2] treated with one of 5 doses of odevixibat [10, 30, 60, 100 or 200 µg/kg] daily for 4 weeks, bile acid levels decreased and symptoms improved in most patients while all patients completed therapy, there were no serious adverse events, and variable changes in ALT levels). 34182185
Deeks ED. Odevixibat: first approval. Drugs. 2021;81:1781-1786. (Review of the history of development, mechanism of action, clinical efficacy, and safety of odevixibat shortly after its approval in the US for the pruritus of PFIC, mentions that a controlled trial of therapy in 62 subjects with PFIC reported adverse events in 33% on odevixibat vs 15% on placebo with ALT elevations in 8.7% to 10.5% on drug [40 and 100 µg/kg] vs 5% on placebo, but there were no episodes of hepatic decompensation or fat-soluble vitamin deficiency). 34499340
Odevixibat (Bylvay) for progressive familial intrahepatic cholestasis-associated pruritus. Med Lett Drugs Ther. 2022;64(1644):28-29.. (Concise review of the mechanism of action, clinical efficacy, safety, and costs of odevixibat shortly after its approval to treat pruritus in progressive familial intrahepatic cholestasis [PFIC], mentions that common adverse events include diarrhea, fat-soluble vitamin deficiencies, and liver test abnormalities). 35171896
Thompson RJ, Arnell H, Artan R, Baumann U, Calvo PL, Czubkowski P, Dalgic B, et al. Odevixibat treatment in progressive familial intrahepatic cholestasis: a randomised, placebo-controlled, phase 3 trial. Lancet Gastroenterol Hepatol. 2022;7:830-842. (Among 62 children with PFIC treated with odevixibat [40 or 120 μg/kg] or placebo once daily for 24 weeks, scratch scores and bile acid levels decreased more with odevixibat than placebo, and adverse events rates were similar in the two groups: all events 83% vs 85%, serious events 7% vs 25%, and ALT elevations 14% vs 5%, most being considered unrelated to therapy and all being transient and not leading to dose modification or discontinuation). 35780807
Ovchinsky N, Aumar M, Baker A, Baumann U, Bufler P, Cananzi M, Czubkowski P, et al. Efficacy and safety of odevixibat in patients with Alagille syndrome (ASSERT): a phase 3, double-blind, randomised, placebo-controlled trial. Lancet Gastroenterol Hepatol. 2024;9:632-645. (Among 52 patients with Alagille’s syndrome and pruritus treated with odevixibat [120 ug/kg] or placebo daily for 24 weeks, scratching scores and bile acid levels decreased more with odevixibat than placebo, while adverse events rates were similar: all events 74% vs 71%, serious events 14% vs 12%, and ALT elevations above 3 times ULN 6% vs 6%). 38670135
Di Giorgio A, Sciveres M, Fuoti M, Calvo P, Cananzi M, Lleo A, Gatti S, et al. Real-world experience with odevixibat in children with progressive familial intrahepatic cholestasis. JHEP Rep. 2024;7:101309. (Among 24 patients with various forms of PFIC treated with odevixibat [40 increased to 120 μg/kg/day] for at least 6 months, serum bile acid levels decreased from a median of 317 to 46 μmol/L, and pruritus scores improved, and while there were no serious adverse events, several patients had increases in ALT, AST, bilirubin, or INR that improved spontaneously without dose adjustment). 40143945

## OTHER REFERENCE LINKS

1. Recent References on Odevixibat: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Odevixibat+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Odevixibat: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Odevixibat)